# Migalastat

## OVERVIEW

### Introduction

Migalastat is pharmacologic chaperone of alpha-galactosidase the intrahepatic enzyme that is deficient in Fabry disease. Clinical experience with migalastat is limited, but it not been linked to serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Migalastat (me' gal a stat) is a small molecule chaperone of alpha-galactosidase A (GLA) the enzyme that is deficient in Fabry disease. The enzyme deficiency results in the intra-lysosomal accumulation of glycosphingolipids in multiple cell types including endothelial, renal and nerve cells, causing damage to kidneys, heart, brain, gastrointestinal tract and peripheral nerves. The disease has an X-linked inheritance, but both males and females can be affected, and the frequency and severity of clinical features vary greatly, apparently dependent upon the amount of residual GLA enzyme activity. In severe cases, the disease presents in childhood with abdominal pain, diarrhea and peripheral neuropathy followed by renal dysfunction that progresses to end stage renal disease in adulthood. Other complications include cardiovascular and cerebrovascular complications including arrhythmias, myocardial infarction, transient ischemic attacks and stoke. Disease severity correlates with amount of accumulation of GLA substrate in affected tissue. Migalastat is a small molecule chaperone which increases GLA activity in cells by directing the enzyme to the proper location in lysosomes. However, only a proportion of patients with Fabry disease have a beneficial response to migalastat, which generally correlates with specific mutations in the GLA gene that can be shown to be responsive to migalastat in vitro as well as in vivo. In several clinical trials, therapy with migalastat was associated with decrease in substrate accumulation in kidney tissue in subjects with gene mutations that could be shown to be amenable to migalastat in vitro. Responses to migalastat were greatest in patients with severe disease, but improvements were measured by changes in substrate accumulation and not by improvement in clinical symptoms or disease outcomes. Migalastat was given accelerated approval in 2018 as oral therapy of Fabry disease in patients who have a variant of the GLA gene that is amenable to its effects. Migalastat is available in tablets of 123 mg under the brand name Galafold. The recommended dose regimen is 123 mg every other day at the same time of day. Side effects are not common but can include headache, upper respiratory symptoms, urinary tract infection, nausea and fever.

### Hepatotoxicity

In placebo-controlled trials, liver test abnormalities were rare and no more common with migalastat than with placebo treatment. What abnormalities occurred were mild and resolved spontaneously without need for dose interruption. During these premarketing clinical trials and since its more widespread clinical availability, no instances of acute liver injury with jaundice have been reported attributable to migalastat. However, the total clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which migalastat might cause serum aminotransferase elevations or liver injury is not known. Migalastat is extensively metabolized by the liver via the cytochrome P450 system (predominantly CYP 2D6 and 3A) and is susceptible to drug-drug interactions with agents that induce or inhibit these enzymes.

### Outcome and Management

The serum aminotransferase elevations that occur on migalastat therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of severe hepatitis, acute liver failure or vanishing bile duct syndrome due to migalastat have been reported.

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Migalastat – Galafold®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Migalastat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Migalastat | 108147-54-2 | C6-H13-N-O4 | Migalastat Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 April 2019

Ferri L, Guido C, la Marca G, Malvagia S, Cavicchi C, Fiumara A, Barone R, et al. Fabry disease: polymorphic haplotypes and a novel missense mutation in the GLA gene. Clin Genet 2012; 81: 224-33. (Review of Fabry disease, an X-linked lysosomal storage disorder caused by deficiency in alpha-galactosidase A [CLA] with a wide spectrum of clinical manifestations and variable mutations in the GLA gene, some of which are responsive to pharmacological chaperone migalastat). 21517827
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that there were no serious adverse events or clinically significant changes in laboratory values).
Germain DP, Hughes DA, Nicholls K, Bichet DG, Giugliani R, Wilcox WR, Feliciani C, et al. Treatment of Fabry's disease with the pharmacologic chaperone migalastat. N Engl J Med 2016; 375: 545-55. (Among 67 patients with Fabry disease treated with migalastat or placebo for 6 months, response rates, defined as amount of GLA substrate inclusions in kidney biopsies, were not significantly greater with migalastat [41% vs 28%] and adverse event rates were similar and there were no "clinically relevant" changes in laboratory test measurements). 27509102
Markham A. Migalastat: first global approval. Drugs 2016; 76: 1147-52. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of migalastat soon after its approval by the European Union; discusses adverse events of headache but does not mention ALT elevations or hepatotoxicity). 27351440
Hughes DA, Nicholls K, Shankar SP, Sunder-Plassmann G, Koeller D, Nedd K, Vockley G, et al. Oral pharmacological chaperone migalastat compared with enzyme replacement therapy in Fabry disease: 18-month results from the randomised phase III ATTRACT study. J Med Genet 2017; 54: 288-96. (Among 53 adults with Fabry disease on enzyme replacement therapy (ERT) with amenable GLA mutations, those switched to migalastat had similar changes in renal and cardiac function as those maintained on ERT; furthermore, adverse event rates were similar, and there were "no clinically relevant treatment group differences" in laboratory test results). 27834756
Müntze J, Gensler D, Maniuc O, Liu D, Cairns T, Oder D, Hu K, et al. Oral chaperone therapy migalastat for treating Fabry disease: enzymatic response and serum biomarker changes after 1 year. Clin Pharmacol Ther 2018 Dec 3. [Epub ahead of print] (Among 14 patients with Fabry disease treated for at last one year, there were significant increases in plasma GLA levels and improvements in cardiac mass index, but worsening of renal function; adverse events not mentioned). 30506669

## OTHER REFERENCE LINKS

1. Recent References on Migalastat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Migalastat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Migalastat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Migalastat)